# Doxorubicin

## OVERVIEW

### Introduction

Doxorubicin, epirubicin, idarubicin and valrubicin are structurally related cytotoxic antineoplastic antibiotics used in the therapy of several forms of lymphoma, leukemia, sarcoma and solid organ cancers. Doxorubicin is associated with a high rate of transient serum enzyme during therapy and to rare instances of clinically apparent acute liver injury with jaundice that can be severe and even fatal. Epirubicin and idarubicin have similar profiles of activity and adverse events as doxorubicin, but have been less commonly used and their potential for causing liver injury has been less well defined. Valrubicin is instilled directly in the bladder as treatment of refractory urinary bladder cancer, has little systemic distribution, and has not been associated with serum enzyme elevations or clinically apparent liver injury.

### Background

Doxorubicin (dox” oh roo’ bi sin), epirubicin (ep” i roo’ bi sin), idarubicin (eye” da roo’ bi sin) and valrubicin (val roo' bi sin) are cytotoxic, anthracycline antibiotics which are believed to act by intercalating between DNA base pairs and uncoiling the DNA helix, which results in inhibition of DNA synthesis and the normal DNA breaking and resealing action of DNA toposiomerase II. These actions lead to apoptosis of rapidly dividing cells. These four agents are all semisynthetic derivatives of daunorubicin and share activities and toxicities. All four agents have severe adverse events particularly myelosuppression that can lead to severe neutropenia and sepsis. These agents should be administered only under the supervision of physicians who are experienced in the use of cancer chemotherapeutic agents and in managing their side effects.

The greatest clinical experience has been with doxorubicin which was previously known as adriamycin. Doxorubicin has potent activity in several forms of cancer, including acute leukemia, lymphomas, sarcomas and solid tumors. Doxorubicin was approved for use in the United States in 1974, and it remains an important agent in many cancer chemotherapeutic regimens. Current indications include treatment of bladder, breast, lung, ovarian stomach and thyroid cancers, Hodgkin disease, acute lymphocytic and non-lymphocytic leukemia, Wilm tumor, neuroblastoma and sarcomas. Doxorubicin is available as a powder for injection and in liquid solution in 10, 20, 50, 100, 150 and 200 mg vials [2 mg/mL] generically and under the brand name Adriamycin. Liposomal formulations are also available. Doxorubicin is typically given intravenously in doses of 60 to 75 mg per meter squared^2^ body surface area every 21 to 28 days. The dosage varies by indication, body surface area and hepatic function. Common side effects include bone marrow suppression, nausea, vomiting, mucositis, diarrhea, headache, dizziness, confusion, neuropathy, alopecia, skin rash and fever. High doses or prolonged therapy with doxorubicin can cause serious cardiac toxicity which is a major dose limiting side effect. Local extravasation of doxorubicin causes severe local tissue injury. Long term folllow up studies of treated patients suggest that secondary malignancies may arise more frequently in those who receive high, total accumulative doses of doxorubicin.

Epirubicin is an analogue of doxorubicin that has activity against many forms of cancer, but is used largely in the treatment of advanced breast cancer. Epirubicin was approved for use in the United States in 1999. Current indications are limited to use in patients with breast cancer who have evidence of lymph node involvement after primary resection of the breast tumor. Epirubicin is available as a solution generically and under the brand name Ellence in single use vials containing 50 or 200 mg [2 mg/mL]. The dose of epirubicin is typically 60 to 100 mg per meter squared given in combination with cyclophosphamide and fluorouracil. It is administered by slow intravenous infusion on days 1 and 8 of 28 day cycles. Common side effects are similar to those of doxorubicin and include cardiac toxicity and secondary malignancies.

Idarubicin is an analogue of doxorubicin that has activity against many forms of cancer, but most convincingly in acute myeloid leukemia (AML). Idarubicin was approved for use in the United States in 1990 and is still in common use in various combination chemotherapeutic regimens. Current indications are limited to use in combination with other antineoplastic agents for acute myelogenous leukemia in adults. Idarubicin is available as a solution generically and under the brand name Idamycin in vials and single dose syringes at concentrations of 1 mg/mL. The dose of idarubicin is typically 12 mg per meter squared body surface area, and the dose is adjusted based upon renal and hepatic function. It is administered by slow intravenous infusion daily for 3 days usually in combination with cytarabine, with repeat courses based on tolerance and efficacy. Common side effects are similar to those of doxorubicin and include cardiac toxicity.

Valrubicin is a synthetic analogue of doxorubicin that is used to treat refractory urinary bladder cancer. Valrubicin has been shown to induce clinical remissions in 18% to 30% of pateints. It was approved as a therapy of bladder cancer in the United States 1998, was removed in 2002 because of manufacturing issues, but reintroduced in 2009. Valrubicin is available only for intravesicular use in 5 mL single dose vials of 200 mg under the brand name Valstar. The recommended dose is 800 mg instilled in the bladder once weekly for 6 weeks. Common side effects include bladder pain and irritation, urgency and dysuria. Systemic absorption is minimal and systemic side effects are uncommon.

### Hepatotoxicity

Serum aminotransferase elevations occur in up to 40% of patients on doxorubicin therapy, but elevations are generally asymptomatic and transient, resolving even with continuation of therapy. However, instances of acute liver injury with symptoms and jaundice have been reported with doxorubicin and rarely also with epirubicin and idarubicin. In most instances, multiple cancer chemotherapeutic agents were being administered and the anthracite antibiotic was believed to enhance the toxicity of the other agents (such as cyclosphosphamide, methotrexate or mercaptopurine). Combination antineoplastic regimens can cause sinusoidal obstruction syndrome, but the role of doxorubicin, epirubicin and idarubicin in this outcome is often not clear. Valrubicin is administered locally in the bladder (intravesical) and has little systemic absorption and has not been linked to serum enzyme elevations during therapy or to clinically apparent liver injury.

Likehood score (doxorubicin): B (likely cause of clinically apparent liver injury).

Likehood score (epirubicin and idarubicin): E* (unproven but suspected cause of clinically apparent liver injury).

Likehood score (valrubicin): E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

While hepatotoxicity from doxorubicin, epirubicin or idarubicin may be rare, it is likely due to direct toxic injury to the liver. Doxorubicin and its analogues are metabolized in the liver via microsomal enzymes, and production of a toxic or immunogenic intermediate may trigger liver injury.

### Outcome and Management

The severity of the liver injury linked to doxorubicin, epirubicin and idarubicin therapy is usually mild and self-limited. These agents on their own have not been specifically linked to cases of acute liver failure, chronic hepatitis or vanishing bile duct syndrome. There is no information on cross sensitivity to hepatic injury among the various cytotoxic antibiotics, but some degree of cross reactivity should be assumed.

Drug Class: Antineoplastic Agents

Other Drugs in the Subclass, Antibiotics, Cytotoxic: Bleomycin, Dactinomycin, Daunorubicin, Mitomycin, Mitoxantrone, Plicamycin

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Doxorubicin – Generic, Adriamycin®

Epirubicin – Generic, Ellence®, Epimycin®

Idarubicin – Generic, Idamycin®

Valrubicin – Valstar®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Doxorubicin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Doxorubicin | 23214-92-8 | C27-H29-N-O11 | Doxorubicin Chemical Structure
Epirubicin | 56420-45-2 | C27-H29-N-O11 | Epirubicin Chemical Structure
Idarubicin | 58957-92-9 | C26-H27-N-O9 | Idarubicin Chemical Structure
Valrubicin | 56124-62-0 | C34-H36-F3-N-O13

## ANNOTATED BIBLIOGRAPHY

References updated: 15 January 2018

Zimmerman HJ. Oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 673-708. (Expert review of hepatotoxicity of cancer chemotherapeutic agents published in 1999 mentions that doxorubicin may enhance the hepatotoxicity of other drugs such as mercaptopurine, cyclophosphamide; it has also been implicated in rare instances of acute and chronic hepatitis like disease).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 541-68. (Review of hepatotoxicity of cancer chemotherapeutic agents; doxorubicin hepatotoxicity is not discussed).
Chabner BA, Bertino J, Cleary J, Ortiz T, Lane A, Supko JG, Ryan DP. Antibiotics. Cytotoxic agents. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1712-5. (Textbook of pharmacology and therapeutics).
Wang JJ, Cortes E, Sinks LF, Holland JF. Therapeutic effect and toxicity of adriamycin in patients with neoplastic disease. Cancer 1971; 28: 837-43. (Among 86 patients with various malignancies who were treated with doxorubicin in various daily regimens and then once weekly, major toxicities were bone marrow suppression, alopecia and gastrointestinal upset; "No significant liver dysfunction was observed as determined by serial serum determinations"). 4329505
Tan C, Etcubanas E, Wollner N, Rosen G, Gilladoga A, Showel J, Murphy ML, Krakoff IH. Adriamycin - an antitumor antibiotic in the treatment of neoplastic diseases. Cancer 1973; 32: 9-17. (Among 284 patients with various malignancies treated with doxorubicin in various dose regimens, major toxicities were bone marrow suppression, alopecia, oral ulcers, fever, anorexia and diarrhea and delayed cardiac effects; "no significant change in liver or renal function...was attributed to Adriamycin"). 4352019
Rodriguez V, Bodey GP, McCredie KB, Freireich EJ, Minow RA, Casey JH, Luna M. Combination 6-mercaptopurine-adriamycin in refractory adult acute leukemia. Clin Pharmacol Ther 1975; 18: 462-6. (Among 19 adults with acute leukemia given 5 day courses of mercaptopurine and doxorubicin every 2-3 weeks, 10 developed severe liver toxicity with hepatocellular damage and cholestasis [bilirubin 1.2 to 13.4 mg/dL, AST 115-220 U/L], 2 had ascending cholangitis and one progressive liver failure and death). 1100309
Schein PS, Winokur SH. Immunosuppressive and cytotoxic chemotherapy: long-term complications. Ann Intern Med 1975; 82: 84-95. (Review of the long term complications of chemotherapy; doxorubicin, like daunorubicin, is associated with cardiac toxicity that is dose limiting; no discussion of doxorubicin hepatotoxicity). 67817
Minow RA, Stern MH, Casey JH, Rodriguez V, Luna MA. Clinico-pathologic correlation of liver damage in patients treated with 6-mercaptopurine and Adriamycin. Cancer 1976; 38: 1524-8. (Combination of doxorubicin [50 mg/m^2^/day], mercaptopurine, vincristine and prednisone for acute leukemia was associated with high rate of hepatotoxicity; in 11 cases bilirubin rising with each course with mild elevations in ALT and Alk P; liver tissue showing central cholestasis with mild hepatocellular necrosis and fatty change). 1068739
Kun LE, Camitta BM. Hepatopathy following irradiation and adriamycin. Cancer 1978; 42: 81-4. (Two 13 year old children [one boy, one girl] developed severe liver injury after irradiation and doxorubicin therapy for malignancies marked by abdominal pain and ascites [bilirubin 3.8 and 0.8 mg/dL, ALT 137 and 31 U/L, Alk P 17.5 and 5.6 Bodansky U/L], one child dying and one recovering; attributed to hepatic irradiation injury enhanced by doxorubicin). 667811
Hollard D, Sotto JJ, Berthier R, Leger J, Michallet M. High rate of long-term survivals in AML treated by chemotherapy and androgenotherapy: a pilot study. Cancer 1980; 45: 1540-8. (Among 31 patients with acute leukemia treated with 3 induction regimens [daunorubicin, vincristine, stanazol and prednisone], 7 developed liver injury, but "the liver toxicity seemed to us of little importance", 4 having liver failure which was fatal in one). 6929214
Avilés A, Herrera J, Ramos E, Ambriz R, Aguirre J, Pizzuto J. Hepatic injury during doxorubicin therapy. Arch Pathol Lab Med 1984; 108: 912-3. (6 patients with acute leukemia treated with doxorubicin, vincristine and prednisone developed liver test abnormalities during induction [bilirubin 0.8-10.0 mg/dL, ALT 480-1050 U/L, Alk P 150-480 U/L], resolving on stopping therapy and recurring in one patient on restarting doxorubicin). 6548368
Schlangen J, Wils J. Liver calcifications following hepatic artery infusion with 5-fluorouracil, adriamycin and mitomycin C (FAM). Rofo 1984; 140: 607-8. (Among 27 patients with hepatic metastases from colorectal cancer treated with intraarterial infusions of fluorouracil, doxorubicin and mitomycin, one developed extensive liver calcifications shown on liver biopsy to be calcifications within necrotic tumor tissue; the patient was asymptomatic and liver test results were not provided). 6429769
Cassileth PA, Begg CB, Bennett JM, Bozdech M, Kahn SB, Weiler C, Glick JH. A randomized study of the efficacy of consolidation therapy in adult acute nonlymphocytic leukemia. Blood 1984; 63: 843-7. (Among 283 patients with acute non-lymphocytic leukemia treated with daunorubicin, cytarabine and thioguanine, 77 also received consolidation therapy, 6 [8%] of whom developed severe hepatotoxicity, but no details given). 6704545
Sznol M, Ohnuma T, Holland JF. Hepatic toxicity of drugs used for hematologic neoplasia. Semin Liver Dis 1987: 237-56. (Overview of hepatotoxicity of antineoplastic agents, mentions that hepatotoxicity was not detected in single agent trials of doxorubicin and daunorubicin, but evidence implicates them when used in combination with mercaptopurine, cisplatin, cyclophosphamide, and etoposide, possibly due to sinusoidal obstruction syndrome). 3317861
Patakfalvi A, Gelencsér E, Sípos J. Drug hepatitis of cholestatic type in association with a FAC-regimen for breast cancer. Acta Med Hung 1987; 44: 377-85. (36 year old woman with metastatic breast cancer developed abnormal liver tests after an initial course of chemotherapy that worsened with a second and third course [bilirubin 1.5, 4.8 and 10.5 mg/dL, ALT 600, 4000 and 360 U/L], injury attributed to cyclophosphamide and doxorubicin). 3444715
Tanaka H, Kawakami M, Kuraishi Y, Meguro S, Ishikawa E. A comparative pathological study of liver injury after different combination chemotherapies for leukemia. Acta Pathol Jpn 1988; 38: 1417-32. (Description of two different patterns of liver injury associated with cancer chemotherapy). 3223277
Pagano L, Sica S, Marra R, Voso MT, Storti S, Di Mario A, Leone G. Oral idarubicin plus cytosine arabinoside in the treatment of acute non lymphoblastic leukemia in elderly patients. Haematologica 1991; 76: 517-8. (Among 18 elderly patients with leukemia treated with cytarabine and oral idarubicin, 2 developed severe liver injury [bilirubin >20 times ULN] and one died, but few details given). 1820991
Hollingshead LM, Faulds D. Idarubicin. A review of its pharmacodynamic and pharmacokinetic properties, and therapeutic potential in the chemotherapy of cancer. Drugs 1991; 42: 690-719. (Review of the structure, mechanism of action, pharmacology, efficacy and safety of idarubicin; side effects and spectrum of action are similar to doxorubicin). 1723369
Soh LT, Ang PT, Sng I, Chua EJ, Ong YW. Fulminant hepatic failure in non-Hodgkin lymphoma patients treated with chemotherapy. Eur J Cancer 1992; 28A: 1338-9. (4 Chinese patients [ages 29-55 years] with HBsAg developed fatal reactivation of hepatitis B after intensive chemotherapeutic regimens that included doxorubicin). 1381211
Coker RJ, James ND, Stewart JS. Hepatic toxicity of liposomal encapsulated doxorubicin. Lancet 1993; 341 (8847): 756. (Among 27 patients with HIV infection and Kaposi sarcoma treated with liposomal encapsulated doxorubicin, serum enzyme elevations occurred during 14-20% of courses, but were invariably mild [<3 times ULN]). 8095649
Avilés A, Guzmán R, Talavera A, García EL, Díaz-Maqueo JC. Randomized study for the treatment of adult advanced Hodgkin's disease: epirubicin, vinblastine, bleomycin, and dacarbazine (EVBD) versus mitoxantrone, vinblastine, bleomycin, and dacarbazine (MVBD). Med Pediatr Oncol 1994; 22: 168-72. (Comparison of different cytotoxic antibiotics combined with bleomycin, vincristine and dacarbazine for Hodgkin disease, found that 6 of 35 given mitoxantrone, but none of 35 treated with epirubicin, developed liver toxicity [AST >3 times ULN], that persisted in 2). 7505877
Bertini M, Freilone R, Botto B, Calvi R, Gallamini A, Gatti AM, Liberati AM, et al. Idarubicin in patients with diffuse large cell lymphomas: a randomized trial comparing VACOP-B (A = doxorubicin) vs VICOP-B (I = idarubicin). Haematologica 1997; 82: 309-13. (Comparison of VACOP vs VICOP induction therapy in 104 patients with lymphoma, found hepatotoxicity occurred in 4% on doxorubicin vs 12% on idarubicin). 9234577
Faggioli P, De Paschale M, Tocci A, Luoni M, Fava S, De Paoli A, Tosi A, Cassi E. Acute hepatic toxicity during cyclic chemotherapy in non Hodgkin's lymphoma. Haematologica 1997; 82: 38-42. (Among 98 patients with non-Hodgkin lymphoma treated with various chemotherapeutic regimens [21 of which included doxorubicin in ProMACE-CytaBOM], 20 had transient ALT elevations and 12 acute hepatitis, 8 of whom were HBsAg positive and frequently had evidence of reactivation). 9107080
Greenberg RE, Bahnson RR, Wood D, Childs SJ, Bellingham C, Edson M, Bamberger MH, et al. Initial report on intravesical administration of N-trifluoroacetyladriamycin-14-valerate (AD 32) to patients with refractory superficial transitional cell carcinoma of the urinary bladder. Urology 1997; 49: 471-5. (Among 32 patients with superficial transitional cell carcinoma of the bladder who were treated with 6 weekly doses of valrubicin instilled directly in the bladder, 13 [42%] had a complete clinical response, side effects were due mainly local irritation in the bladder and there were no changes in routine laboratory tests). 9123721
Steinmetz HT, Schulz A, Staib P, Scheid C, Glasmacher A, Neufang A, Franklin J, et al. Phase-II trial of idarubicin, fludarabine, cytosine arabinoside, and filgrastim (Ida-FLAG) for treatment of refractory, relapsed, and secondary AML. Ann Hematol 1999; 78: 418-25. (Trial of idarubicin with 3 other agents in patients with refractory, relapsed or secondary AML identified major toxicities of bone marrow suppression, infections, nausea, diarrhea, fever and bleeding, but serious hepatic toxicity was "rarely observed"). 10525830
Valrubicin for bladder cancer. Med Lett Drugs Ther 1999; 41 (1049): 32. (Concise review of the mechanism of action, clinical efficacy, safety and costs of valrubicin shortly after it was approved for use in the US as treatment of bladder cancer; no mention of liver injury or serum enzyme elevations). 10232952
Steinberg G, Bahnson R, Brosman S, Middleton R, Wajsman Z, Wehle M. Efficacy and safety of valrubicin for the treatment of Bacillus Calmette-Guerin refractory carcinoma in situ of the bladder. The Valrubicin Study Group. J Urol 2000; 163: 761-7. (Among 90 patients with recurrent, refractory in situ bladder cancer who received 6 weekly intravesical instillations of valrubicin, 19 [21%] had a complete response and adverse events inlcuded bladder irritation, frequency and dysuria). 10687972
Avvisati G, Petti MC, Lo-Coco F, Vegna ML, Amadori S, Baccarani M, Cantore N, et al.; GIMEMA (Gruppo Italiano Malattie Ematologische dell'Adulto) Italian Cooperative Group. Induction therapy with idarubicin alone significantly influences event-free survival duration in patients with newly diagnosed hypergranular acute promyelocytic leukemia: final results of the GIMEMA randomized study LAP 0389 with 7 years of minimal follow-up. Blood 2002; 100: 3141-6. (Comparison of induction therapy with idarubicin alone versus idarubicin and cytarabine in 257 patients with acute leukemia, found hepatotoxicity in 7.6% on idarubicin alone [1 death from liver failure] versus 7.1% on the combination, but few details given). 12384411
Ma B, Yeo W, Hui P, Ho WM, Johnson PJ. Acute toxicity of adjuvant doxorubicin and cyclophosphamide for early breast cancer - a retrospective review of Chinese patients and comparison with an historic Western series. Radiother Oncol 2002; 62: 185-9. (Among 85 women with breast cancer treated with doxorubicin and cyclophosphamide, severe hepatotoxicity occurred only in HBsAg positive patients). 11937245
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, several cases were attributed to antineoplastic agents [such as mercaptopurine, cyclophosphamide, docetaxel, temozolomide, bortezomib and imatinib], but none to the cytotoxic antibiotics such as doxorubicin or daunorubicin). 18955056
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, including 2 attributed to antineoplastic agents, 1 to melphalan and 1 to gemtuzumab, but none to a cytotoxic antibiotic such as bleomycin, doxorubicin or daunorubicin). 20949552
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Among 176 reports of drug induced liver injury from Latin American published between 1996 and 2012, 10 were attributed to antineoplastic agents including methotrexate, imatinib, cyclophosphamide, procarbazine and tamoxifen, but none were attributed to doxorubicin or other cytotoxic antibiotics).24552865
Damodar G, Smitha T, Gopinath S, Vijayakumar S, Rao Y. An evaluation of hepatotoxicity in breast cancer patients receiving injection Doxorubicin. Ann Med Health Sci Res 2014; 4: 74-9. (Among 46 patients with breast cancer treated with doxorubicin, 30% developed ALT, AST or bilirubin elevations, but the duration and severity of the abnormalities was not provided). 24669335
Cookson MS, Chang SS, Lihou C, Li T, Harper SQ, Lang Z, Tutrone RF. Use of intravesical valrubicin in clinical practice for treatment of nonmuscle-invasive bladder cancer, including carcinoma in situ of the bladder. Ther Adv Urol 2014; 6: 181-91. (Among 113 patients with superficial bladder cancer treated with intravesical instillation of valrubicin, local advrse events occurred in 50% and were usually mild; no mention of systemic effects and none of the 7 listed serious adverse events were liver related). 25276228
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 49 were attributed to antineoplastic agents, but none to doxorubicin, epirubicin or idarubicin). 25754159
Lerner SP, Bajorin DF, Dinney CP, Efstathiou JA, Groshen S, Hahn NM, Hansel D, et al. Summary and recommendations from the National Cancer Institute's Clinical Trials Planning Meeting on Novel Therapeutics for Non-Muscle Invasive Bladder Cancer. Bladder Cancer 2016; 2: 165-202. (Research workshop on needs for innovative therapies for bladder cancer, there having been no new FDA approved drugs since the introduction of valrubicin in 1998). 27376138
Tap WD, Jones RL, Van Tine BA, Chmielowski B, Elias AD, Adkins D, Agulnik M, et al. Olaratumab and doxorubicin versus doxorubicin alone for treatment of soft-tissue sarcoma: an open-label phase 1b and randomised phase 2 trial. Lancet 2016; 388 (10043): 488-97. (Among 133 patients with soft tissue sarcoma treated with doxorubicin with or without olaratumab for up to 8 cycles of 21 days, overall and progression free survival improved with addition of olaratumab, but adverse event rates were also higher, although there were no elevations in serum ALT or AST levels above 5 times ULN in either group). 27291997
Janni W, Harbeck N, Rack B, Augustin D, Jueckstock J, Wischnik A, Annecke K, et al. Randomised phase III trial of FEC120 vs EC-docetaxel in patients with high-risk node-positive primary breast cancer: final survival analysis of the ADEBAR study. Br J Cancer 2016; 114: 863-71. (Among 1493 women with metastatic breast cancer treated with epirubicin and cyclophosphamide with either fluorouracil or docetaxel, there were no differences in overall survival between the treatment arms, but serious adverse events were higher with fluorouracil [30% vs 23%] while ALT elevations above 5 times ULN occurred at similar low rates [ 0.9% vs 1.5%]). 27031854
Brown KT, Do RK, Gonen M, Covey AM, Getrajdman GI, Sofocleous CT, Jarnagin WR, et al. Randomized trial of hepatic artery embolization for hepatocellular carcinoma using doxorubicin-eluting microspheres compared with embolization with microspheres alone. J Clin Oncol 2016; 34: 2046-53. (Among 101 patients with hepatocellular carcinoma treated with transarterial embolization using microspheres with or without doxorubicin-loading, there were no differences in overall or progression free survival or in adverse event rates; ALT elevations were not specifically mentioned). 26834067
Nam HC, Jang B, Song MJ. Transarterial chemoembolization with drug-elutingbeads in hepatocellular carcinoma. World J Gastroenterol 2016; 22: 8853-61. (Review of the safety and efficacy of doxorubicin eluting beads for use in TACE treatment of hepatocellular carcinoma discusses the advantage of this treatment approach because of lack or minimal systemic exposure to doxorubicin). 27833376
Seddon B, Strauss SJ, Whelan J, Leahy M, Woll PJ, Cowie F, Rothermundt C, et al. Gemcitabine and docetaxel versus doxorubicin as first-line treatment in previously untreated advanced unresectable or metastatic soft-tissue sarcomas (GeDDiS): a randomised controlled phase 3 trial. Lancet Oncol 2017; 18 (10): 1397-1410. (Among 257 patients with advanced metastatic soft tissue sarcoma treated with 6 cycles of doxorubicin vs gemcitabine with docetaxil, progression free survival was the same with both treatments and adverse event rates were comparable; ALT elevations occurring in 27% vs 29% which were above 5 times ULN in 1% vs 1%). 28882536
Tap WD, Papai Z, Van Tine BA, Attia S, Ganjoo KN, Jones RL, Schuetze S, et al. Doxorubicin plus evofosfamide versus doxorubicin alone in locally advanced, unresectable or metastatic soft-tissue sarcoma (TH CR-406/SARC021): an international, multicentre, open-label, randomised phase 3 trial. Lancet Oncol 2017; 18: 1089-103. (Among 640 patients with advanced soft tissue sarcoma treated with doxorubicin with or without evofosfamide, overall survival was the same in both groups, while side effects were less with monotherapy including ALT elevations [1% vs 3.5%], none of which were above 5 times ULN). 28651927
Earl HM, Hiller L, Howard HC, Dunn JA, Young J, Bowden SJ, McDermaid M, et al.; tAnGo trial collaborators. Addition of gemcitabine to paclitaxel, epirubicin, and cyclophosphamide adjuvant chemotherapy for women with early-stage breast cancer (tAnGo): final 10-year follow-up of an open-label, randomised, phase 3 trial. Lancet Oncol 2017; 18: 755-69. (Among 3152 women with early stage breast cancer treated with epirubicin, paclitaxel and cyclophosphamide with or without gemcitabine, disease free survival did not differ between the two treatment arms, while adverse events were more frequent with the addition of gemcitabine; no mention of ALT elevations or hepatotoxicity). 28479233
Monk BJ, Brady MF, Aghajanian C, Lankes HA, Rizack T, Leach J, Fowler JM, et al. A phase 2, randomized, double-blind, placebo- controlled study of chemo-immunotherapy combination using motolimod with pegylated liposomal doxorubicin in recurrent or persistent ovarian cancer: a Gynecologic Oncology Group partners study. Ann Oncol 2017; 28: 996-1004. (Among 297 women with advanced ovarian cancer treated with pegylated liposomal doxorubicin with or without motolimod [a toll-like receptor 8 agonist], overall survival and adverse event rates were similar in the 2 treatment arms; no mention of ALT elevations or hepatotoxicity). 28453702
Harbeck N, Saupe S, Jäger E, Schmidt M, Kreienberg R, Müller L, Otremba BJ, et al.; PELICAN Investigators. A randomized phase III study evaluating pegylated liposomaldoxorubicin versus capecitabine as first-line therapy for metastatic breastcancer: results of the PELICAN study. Breast Cancer Res Treat 2017; 161: 63-72. (Among 210 women with metastatic breast cancer treated with pegylated liposomal doxorubicin every 28 days or capecitabine, there were no differences in time to progression between the two treatment arms while adverse events were more common with capecitabine; no mention of ALT elevations or hepatotoxicity). 27798749

## OTHER REFERENCE LINKS

1. Recent References on Doxorubicin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Doxorubicin+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Doxorubicin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Doxorubicin)